# Acoramidis

## OVERVIEW

### Introduction

Acoramidis is transthyretin stabilizer used for the treatment of adults with the cardiomyopathy of both wild-type and hereditary transthyretin-mediated amyloidosis to reduce cardiovascular morbidity and mortality. Acoramidis has been associated with minor liver test abnormalities during therapy but has not been linked instances of clinically apparent liver injury.

### Background

Acoramidis (a’ co ram” i dis ) is a stabilizer of transthyretin, a serum protein made in the liver whose major function is transport of vitamin A and thyroxine. Rare mutations in the transthyretin gene result in misfolding of the protein and accumulation of large amyloid deposits of transthyretin molecules, most prominently in peripheral nerves and the heart. Patients with hereditary transthyretin amyloidosis typically present with polyneuropathy or autonomic dysfunction followed by cardiomyopathy, which if untreated is usually fatal within 5 to 12 years. Rarely, wild-type transthyretin also can result in overproduction and deposition of misfolded transthyretin in amyloid clusters. Acoramidis causes stabilization of the transthyretin molecule in the full tetrameric form such that it is less likely to break into monomers that can misfold and create amyloid clusters. In preregistration open label studies, acoramidis increased stable transthyretin levels and led to improvements all-cause mortality and decrease in cardiovascular hospitalizations. Acoramidis was the second transthyretin stabilizer to be approved for use in the United States as treatment of the cardiomyopathy of wild-type and hereditary transthyretin-mediated amyloidosis in adults in 2024 (the first being tafamidis in 2019). Acoramidis is available in tablets of 356 mg under the brand name Attruby, the recommended dose being 712 mg (2 tablets) twice daily. In clinical trials of acoramidis, side effects were uncommon and similar in frequency overall to those of placebo. Slightly more frequent with acoramidis therapy was diarrhea (23% vs 8%) and upper abdominal pain (5.5% vs 1.4%). Mild and reversable serum creatinine levels were also increased with acoramidis therapy. Transthyretin functions as a carrier and transporter of vitamin A and thyroxine, and therapy with acoramidis can alter serum concentrations of these molecules but does not appear to affect thyroid function or vitamin A status.

### Hepatotoxicity

In the registration trial of acoramidis, transient mild ALT and AST elevations were not uncommon, but elevations in ALT above 3 times ULN were infrequent and no more common with acoramidis than placebo (0.9% vs 0.5%), most of which were attributed to heart failure or its treatment. No patient required drug discontinuation because of liver test abnormalities and none developed clinically apparent liver injury or elevations in serum aminotransferases accompanied by jaundice. Since its approval, clinical experience with acoramidis has been limited, but there have been no published case reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which acoramidis might cause liver injury is not clear. Acoramidis is a small molecule that binds to transthyretin and is metabolized by glucuronidation. Acoramidis is not metabolized by P450 enzymes, but drug levels may be decreased by glucuronosyltransferase inducers and strong CYP3A inducers which increase glucuronidation.

### Outcome and Management

The serum aminotransferase elevations that occur on acoramidis therapy are unlikely to be due to the drug therapy and rarely require dose modification or discontinuation. Persistent ALT or AST elevations arising during therapy should lead to evaluation of their possible causes. There is no information on cross sensitivity to liver injury among the various other therapies for transthyretin-associated amyloidosis.

Drug Class: Genetic Disorder Agents

Drugs for Hereditary Transthyretin Amyloidosis: Eplontersen, Inotersen, Patisiran, Tafamidis, Vutrisiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acoramidis – Attruby®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acoramidis)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acoramidis | 1446711-81-4 | C15-H17-FN2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of acoramidis).
FDA. Integrated Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/216540Orig1s000IntegratedR.pdf (FDA website with the product labels and integrated review of the data on efficacy and safety provided by the sponsor in support of approval of acoramidis as therapy of transthyretin amyloid cardiomyopathy mentions that “hepatic injury” arose in 2.1% of acoramidis vs 3.3% of placebo recipients, and ALT elevations above 3 times ULN arose in 0.9% vs 0.5%).
Maurer MS. Overview of current and emerging therapies for amyloid transthyretin cardiomyopathy. Am J Cardiol. 2022;185 Suppl 1:S23-S34. (Review of approaches to therapy of amyloid transthyretin cardiomyopathy including the transthyretin stabilizers [tafamidis, acoramidis] and transthyretin gene silencing or knockdown agents [patisiran, vutrisiran, inotersen, eplontersen, CRISPR-Cas9]; no mention of liver related adverse events). 36371281
Razvi Y, Judge DP, Martinez-Naharro A, Ioannou A, Venneri L, Patel R, Gillmore JD, et al. Effect of acoramidis on myocardial structure and function in transthyretin amyloid cardiomyopathy: insights from the ATTRibute-CM Cardiac Magnetic Resonance (CMR) Substudy. Circ Heart Fail. 2024;17:e012135. (Among 52 adults with transthyretic amyloid cardiomyopathy being treated in a placebo controlled trial who underwent repeat cardiac magnetic resonance imaging, those receiving acoramidis showed favorable trends in improved or stable left ventricular mass and function). 39465243
Gillmore JD, Judge DP, Cappelli F, Fontana M, Garcia-Pavia P, Gibbs S, Grogan M, et al.; ATTRibute-CM Investigators. Efficacy and safety of acoramidis in transthyretin amyloid cardiomyopathy. N Engl J Med. 2024;390:132-142. (Among 632 adults with transthyretin amyloid cardiomyopathy treated with acoramidis [800 mg] or placebo twice daily for up to 30 months, “a significant treatment effect for acoramidis in a four-step hierarchical analysis” was found and adverse event rates were similar in the two groups [all 98% vs 98%, serious 55% vs 65%]; no mention of ALT elevations or hepatotoxicity). 38197816
Judge DP, Gillmore JD, Alexander KM, Ambardekar AV, Cappelli F, Fontana M, García-Pavía P, et al. Long-term efficacy and safety of acoramidis in ATTR-CM: initial report from the open-label extension of the ATTRibute-CM Trial. Circulation. 2025;151(9):601-611. (Among 389 patients with transthyretin amyloid cardiomyopathy who participated in the large, placebo-controlled registration trial of acoramidis for 30 months [Gillmore 2024] who were subsequently enrolled in an open label extension study, cardiovascular mortality and hospitalization rates in those on continuous therapy from month 0 to 42 remained below those who were crossed over to acoramidis at month 30, and there were “no clinically important safety issues newly identified”; no mention of ALT elevations or hepatotoxicity). 39556242
Ruberg FL, Maurer MS. Cardiac amyloidosis due to transthyretin protein: a review. JAMA. 2024;331:778-791. (Review of the epidemiology, pathophysiology, clinical presentation, diagnosis, and treatment of transthyretin amyloid cardiomyopathy; no mention of liver related adverse events). 38441582

## OTHER REFERENCE LINKS

1. Recent References on Acoramidis: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acoramidis/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Acoramidis: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acoramidis)